# Tamsulosin

## OVERVIEW

### Introduction

Tamsulosin is a selective alpha-1a adrenergic antagonist used in the therapy of benign prostatic hypertrophy. Tamsulosin therapy is associated with a low rate of serum aminotransferase elevations, but clinically apparent acute liver injury due to tamsulosin is very rare.

### Background

Tamsulosin is a selective alpha-1a adrenergic antagonist which is used to treat signs and symptoms of benign prostatic hypertrophy. Tamsulosin inhibits alpha adrenergic receptors present on smooth muscle in the bladder neck and prostate (alpha-1a adrenergic receptors). It has minimal effects on alpha-1b adrenergic receptors present in arterioles which are responsible for the antihypertensive effects of the nonspecific alpha-1 adrenergic blockers. The effects of the agent on smooth muscle of the bladder neck and prostate cause improvement in urine flow in men with partial obstruction due to benign prostatic hypertrophy. Tamsulosin was approved for use in the United States in 2007 for treatment of symptoms of urinary hesitancy due to benign prostatic hypertrophy. Tamsulosin is available in capsules of 0.4 and 0.8 mg in several generic forms and under the trade name Flomax. The recommended dose is 0.4 to 0.8 mg once daily. Side effects include retrograde ejaculation, orthostatic hypotension, dizziness, diarrhea, thirst, nasal stuffiness and headache. Rare, but potentially severe adverse reactions include othrostatic hypotension, priapism and intraoperative floppy lens syndrome.

### Hepatotoxicity

Tamsulosin has been associated with a low rate of serum aminotransferase elevations (<2%) that in controlled trials was no higher than with placebo or comparative agent therapy. These elevations were transient and did not require dose modification. A single case report of clinically apparent acute liver injury due to tamsulosin has been published. The onset of injury was 11 days after starting the medication, and the clinical picture was similar to acute cholecystitis with jaundice, abdominal pain and fever, but a hepatocellular pattern of serum enzyme elevations. No evidence of biliary disease was identified, and the patient recovered rapidly when tamsulosin was withheld. Allergic and autoimmune features were not present. Among the alpha adrenergic receptor antagonists, the most frequently implicated agent in causing liver injury has been alfuzosin with only single, and not well documented cases linked to other alpha blockers. Thus, acute symptomatic liver injury due to tamsulosin is rare and it seems to resemble the mild and self-limited forms of liver injury linked to other alpha-1 adrenergic blockers.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum aminotransferase elevations and rare instances of acute liver injury associated with tamsulosin is not known. Tamsulosin is extensively metabolized by the liver by the cytochrome P450 enzymes (predominantly CYP 3A4 and 2D6) and generation of a mildly toxic intermediate is a possible explanation.

### Outcome and Management

No instances of acute liver failure or chronic liver injury have been reported in association with tamsulosin or other alpha adrenergic blockers. There is no information on cross reactivity of the liver injury among the various adrenergic receptor antagonists such as alfuzosin, silodosin, doxazosin and terazosin, but similarity of chemical structure suggests that cross sensitivity may be present.

References to the safety and potential hepatotoxicity of tamsulosin are given in the Overview on the Alpha-1 Adrenergic Receptor Antagonists.

Drug Class: Benign Prostatic Hypertrophy Agents

Other Drugs in the Class:

- Alpha-1 Adrenergic Receptor Antagonists
  - Alfuzosin, Doxazosin, Silodosin, Terazosin
- 5-Alpha Reductase Inhibitors
  - Dutasteride, Finasteride

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tamsulosin – Generic, Flomax®

DRUG CLASS

Benign Prostatic Hypertrophy Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tamsulosin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tamsulosin | 106133-20-4 | C20-H28-N2-O5-S | Tamsulosin Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Tamsulosin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tamsulosin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tamsulosin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tamsulosin)